# Antituberculosis Agents

## OVERVIEW

Infection with mycobacterium tuberculosis remains an uncommon, but clinically important problem in the United States despite sustained public health efforts and the availability of effective antituberculous therapy for more than 50 years. An estimated 12,000 to 15,000 cases of active tuberculosis occur yearly in the United States and account for at least 600 deaths annually. Worldwide, tuberculosis is a major cause of morbidity and mortality, ranking among the top five most fatal infectious diseases.

The modern era of antituberculosis medications began in 1944 with the development of streptomycin for which Selman Waksman received the Nobel Prize. Subsequently, more potent agents with wider activity and better tolerability were developed including p-aminosalicylic acid (PAS) in 1949, isoniazid in 1952, pyrazinamide in 1954, ethambutol in 1962, rifampin in 1963 and cycloserine in 1964. The development of chemotherapy for tuberculosis is one of the great achievements of biomedical research in the 20th Century.

Importantly, however, the major first line antituberculosis medications have hepatotoxic potential, including clinically apparent acute liver disease as well as acute liver failure and death or need for emergency liver transplantation. Furthermore, combination therapy which is required for the therapy of active tuberculosis appears to be associated with a higher rate of hepatotoxicity than occurs with the individual agents by themselves.

The current recommended therapy of active tuberculosis is the combination of at least two potent antimycobacterial agents for 6 to 9 months, examples being isoniazid, rifampin, pyrazinamide and ethambutol (the two latter agents often given in a 4-drug regimen for the first 2 months in patients with suspected drug resistant disease). PAS (p-aminosalicylic acid) is now rarely used, because of poor tolerance and its known hepatotoxicity. Ethambutol is used in instances of suspected or proven multidrug resistance. Other agents similar to rifampin which have activity against mycobacterium tuberculosis and several of the atypical mycobacteria include rifabutin and rifapentine. Second line agents, used in situations of toxicity of the first line agents or for multidrug resistance, include amikacin, azithromycin, capreomycin, cycloserine, ethionamide, levofloxacin, moxifloxacin, and streptomycin which in general have lower rates of hepatotoxicity.

Therapy is also recommended for latent tuberculosis or the finding of a positive protein derivative skin test (PPD), particularly in a high risk individual, after known exposure or with known skin test conversion. The primary regimen recommended for latent tuberculosis is a 9 month course of isoniazid, daily or twice weekly. The twice weekly regimen is appropriate for "directly observed therapy" (DOT), which helps in compliance and early detection and management of adverse reactions including hepatotoxicity. Alternative approaches include a 6 month course of isoniazid daily or twice weekly (DOT), a 4 month course of rifampin daily, and a 3 month course of isoniazid and rifapentine once weekly (DOT). The previous recommendation for using a 4 month course of rifampin and pyrazinamide is no longer recommended because of the potential for severe hepatotoxicity.

Regularly updated recommendations on the diagnosis, prevention and therapy of tuberculosis are available from the Centers for Disease Control and Prevention at: http://www.cdc.gov/tb/.

First line medications used in the therapy of tuberculosis include ethambutol, isoniazid, pyrazinamide, rifabutin, rifampin, and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, amikacin, levofloxacin, moxifloxacin, and para-aminosalicylic acid (PAS) (the latter is not discussed on this website). Finally, bedaquiline, the first new medication specifically for treatment of tuberculosis in more than forty years, was approved for use in the United States in 2012. Bedaquiline is currently limited in availability and is recommended only as directly observed therapy of multidrug resistant tuberculosis when an effective treatment regimen cannot otherwise be provided.

The following antituberculosis medications are discussed individually:

- Bedaquiline
- Capreomycin
- Cycloserine
- Ethambutol
- Ethionamide
- Isoniazid
- Pretomanid
- Pyrazinamide
- Rifabutin
- Rifampin
- Rifapentine
- Streptomycin